# Salsalate

## OVERVIEW

### Introduction

Salsalate is a nonacetylated dimer of salicylic acid that is used in the treatment of chronic arthritis as an analgesic and antipyretic. Salsalate can cause moderate serum aminotransferase elevations when given in high doses in a manner similar to aspirin.

### Background

Salsalate (sal' sa late) is a dimer of salicylic acid that has antiinflammatory, analgesic and antipyretic actions similar to aspirin. The antiinflammatory and analgesic effects of salsalate are probably mediated by inhibition of prostaglandin synthesis. Although available for several decades, salsalate is not commonly used. Current indications include treatment of chronic arthritis due to osteoarthritis or rheumatoid arthritis. Salsalate is also used for minor to moderate pain. Salsalate is available as tablets of 500 and 750 mg in multiple generic forms and previously under the brand name of Disalcid. The recommended regimen is 750 to 1500 mg twice daily, based upon response and tolerance. Common side effects are intestinal upset, nausea, headache, somnolence, dizziness, and tinnitus.

### Hepatotoxicity

Prospective studies show that a proportion of patients taking salsalate experience at least transient serum aminotransferase elevations particularly when it is given in higher doses. These abnormalities may resolve even with drug continuation or after dose reduction. Marked aminotransferase elevations (>10 fold elevated) occur rarely except with use of higher doses (4 g daily or more) in a manner similar to aspirin. Clinically apparent liver injury with jaundice from salsalate has not been reported and must be very rare. Salsalate is probably capable of inducing Reye syndrome in a susceptible child or adolescent and, like aspirin, should be avoided in those age groups.

Likelihood score: A[HD] (well established cause of liver injury if given in high doses).

### Mechanism of Injury

The mechanism of salsalate hepatotoxicity is likely a direct cytotoxic effect of high doses, similar to that of aspirin.

### Outcome and Management

Salsalate hepatotoxicity has been marked by aminotransferase elevations without jaundice. Some patients have nonspecific symptoms or gastrointestinal upset. There have been no reported cases of acute hepatitis, acute liver failure or vanishing bile duct syndrome related to salsalate. Aminotransferase elevations during therapy can often be managed by dose adjustment.

Drug Class: Salicylates

Other Drugs in the Class: Aspirin, Diflunisal, Trisalicylate

## CASE REPORT

### Case 1. Acute enzyme elevations due to high dose salsalate therapy.(1)

A 27 year old man with HIV infection was enrolled in an experimental study of the effects of salsalate on endothelial cell function. He was without symptoms of HIV infection or liver disease, was not receiving antiretroviral therapy and had normal baseline liver tests (Table). He was started on salsalate (750 mg orally twice daily) and monitored closely. After 10 days he developed nausea and abdominal pain and salsalate was stopped. He had no previous history of liver disease, alcohol abuse or drug allergies. He had been taking weekly prophylactic sulfamethoxazole/trimethoprim for several months. Physical examination was unrevealing. Serum enzymes were markedly elevated [ALT 1101 U/L, AST 532 U/L, Alk P 77 U/L, bilirubin normal]. The while blood cell count was normal with 1% eosinophils. The INR was 1.0. He tested positive for anti-HBs and anti-HBc without HBsAg. Tests for hepatitis A and C were negative. He had low levels of serum autoantibodies (ANA 1:40, SMA 1:80), but globulin levels were normal (albumin 4.3 g/L, globulins 2.9 g/dL). His symptoms resolved within days of stopping salsalate and serum enzymes were normal three weeks later.

#### Key Points

Medication: | Salsalate (1.5 grams daily)
Pattern: | Hepatocellular (R= 40)
Severity: | 1+ (enzyme elevations without jaundice)
Latency: | 10 days
Recovery: | Rapid (19 days)
Other medications: | Sulfamethoxazole/Trimethoprim

#### Laboratory Values

Days After Starting | Days After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 21 | 61 | 0.9
0 | | 33 | 52 | 1.2
10 | 0 | 1101 | 77 | 0.9 | Nausea
17 | 7 | 207 | 79 | 0.8 | Asymptomatic
29 | 13 | 38 | 67 | 0.7
6 months | 6 months | 54 | 67 | 0.9
Normal Values | | <45 | <95 | <1.2

#### Comment

A very convincing case of salsalate induced hepatotoxicity. The onset was within a few days of starting the drug. The patient was mildly symptomatic, but not jaundiced. There were no changes in alkaline phosphatase or bilirubin levels. Recovery was rapid once salsalate was stopped, and there were no other obvious causes of liver injury. The clinical phenotype was acute hepatic necrosis rather than hepatitis. The dose of salsalate was lower than that usually associated with serum aminotransferase elevations, suggesting an element of increased susceptibility to this injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Salsalate – Generic, Disalcid® (not available in US)

DRUG CLASS

Antiinflammatory Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=SALSALATE)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Salsalate | 552-94-3 | C14-H10-O5

## CITED REFERENCE

1 Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology.

## ANNOTATED BIBLIOGRAPHY

References updated: 15 August 2020

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. Chapter 19: The NSAIDS. In Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott Williams & Williams, 1999, pp. 517-41. (Review of hepatotoxicity of salicylates published in 1999, discusses aspirin but not salsalate specifically).
Lewis JH, Stine JG. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. pp. 370-402. (Expert review of liver injury caused by NSAIDs mentions that salsalate can cause aminotransferase elevations).
Grossner T, Smyth EM, Fitzgerald GA. Pharmacology of inflammation, fever, pain, and gout. In, Brunton LL, Hilal-Dandan R, Knollman BC. Goodman & Gilman’s The pharmacological basis of therapeutics, 13th ed. New York: McGraw-Hill, 2018. p. 685-708. (Textbook of pharmacology and therapeutics).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, salsalate was implicated in one patient who developed marked ALT elevations without jaundice [bilirubin 0.9 mg/dL, ALT 1101 U/L, Alk P 77 U/L] 10 days after starting salsalate [1.5 g daily], resolving within 3 weeks of stopping: Case 1).
Juluri R, Gupta S, Vuppalanchi R. (2009). Serum concentration-dependent hepatotoxicity in individuals receiving oral salsalate. Dig Dis Sci. (Prospective study in 11 patients with HIV infection given 1500 mg salsalate twice daily for 8 weeks; 4 patients developed ALT elevations [mean=27 rising to 482 and later to 116 U/L], 2 had symptoms, all resolved rapidly with stopping).
Goldfine AB, Fonseca V, Jablonski KA, Pyle L, Staten MA, Shoelson SE. (2010). TINSAL-T2D (Targeting Inflammation Using Salsalate in Type 2 Diabetes) Study Team. The effects of salsalate on glycemic control in patients with type 2 diabetes: a randomized trial. Ann Intern Med. (Controlled trial of 14 weeks of 3-4 g of salsalate daily vs placebo in 54 patients with diabetes found decreases in serum HgA1c and glucose, but no change in serum ALT, AST or GGT; dose limiting side effect was tinnitus).
Hileman CO, Carman TL, Gripshover BM, O'Riordan M, Storer NJ, Harrill DE, White CA, et al. (2010). Salsalate is poorly tolerated and fails to improve endothelial function in virologically suppressed HIV-infected adults. AIDS. (Open label study of 13 weeks of salsalate [4 g daily] vs no treatment in 40 patients with HIV infection on antiretroviral therapy found no effect on markers of inflammation and poor tolerance, with minor [<3 times ULN] ALT elevations in 6 [30%]).
Hawley SA, Fullerton MD, Ross FA, Schertzer JD, Chevtzoff C, Walker KJ, Peggie MW, et al. (2012). The ancient drug salicylate directly activates AMP-activated protein kinase. Science. (Studies in vitro and in vivo showed that salicylate activates AMP-activate protein kinase independent of changes in AMP levels).
Faghihimani E, Amini M, Adibi A, Naderi Z, Toghiani A, Adibi P. (2013). Evaluating the efficacy of salsalate on prediabetic and diabetic patients with fatty liver: A randomized clinical trial. J Res Pharm Pract. (Among 34 diabetic and 86 prediabetic adults treated with salsalate [1.5 g/day] or placebo for an unreported period of time, serum ALT and AST did not change while results of fasting blood sugar and lipids were not reported).
Goldfine AB, Fonseca V, Jablonski KA, Chen YD, Tipton L, Staten MA, Shoelson SE. (2013). Targeting Inflammation using Salsalate in Type 2 Diabetes Study Team. Salicylate (salsalate) in patients with type 2 diabetes: a randomized trial. Ann Intern Med. (Among 286 patients with type 2 diabetes treated with salsalate [3.5 g/day] or placebo for 48 weeks, HgA1c levels decreased and fasting glucose levels were lower in salsalate treated subjects, while ALT levels trended to be lower as well).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 28 were due to nonsteroid antiinflammatory agents, one to salsalate but none to choline magnesium trisalicylate).
Alderete TL, Sattler FR, Richey JM, Allayee H, Mittelman SD, Sheng X, Tucci J, Gyllenhammer LE, Grant EG, Goran MI. (2015). Salsalate treatment improves glycemia without altering adipose tissue in nondiabetic obese Hispanics. Obesity (Silver Spring). (Among 24 obese young Hispanic adults treated with salsalate [4 g/day] or placebo for 4 weeks, fasting glucose and free fatty acids declined without change in liver fat or body weight with salsalate therapy and “liver function tests” did not change in either group).
Hauser TH, Salastekar N, Schaefer EJ, Desai T, Goldfine HL, Fowler KM, Weber GM, Welty F, Clouse M, Shoelson SE, Goldfine AB, Targeting Inflammation Using Salsalate in Cardiovascular Disease (TINSAL-CVD) Study Team. (2016). Effect of Targeting Inflammation With Salsalate: The TINSAL-CVD randomized clinical trial on progression of coronary plaque in overweight and obese patients using statins. JAMA Cardiol. (Among 257 patients with stable coronary artery disease treated with salsalate [3.5 g/day] or placebo for 30 months, there were no differences in changes in coronary plaque or calcium scores, but rates of atrial arrhythmias and tinnitus were higher with salsalate; no serious hepatic adverse events and no changes in median ALT or AST levels ).
Salastekar N, Desai T, Hauser T, Schaefer EJ, Fowler K, Joseph S, Shoelson SE, et al., TINSAL-CVD Study Team. (2017). Salsalate improves glycaemia in overweight persons with diabetes risk factors of stable statin-treated cardiovascular disease: A 30-month randomized placebo-controlled trial. Diabetes Obes Metab. (Among a subgroup of 192 nondiabetic patients treated with salsalate or placebo for 30 months [TINSAL-CVD; Hauser 2016], there was a sustained decrease in HgA1c and fasting glucose levels with salsalate treatment as well as slight decreases in serum aminotransferase levels and no difference in rates of hepatic adverse events between the two groups [1% in both]).

## OTHER REFERENCE LINKS

1 Recent References on Salsalate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=salsalate+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Salsalate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=salsalate)